# Comfrey

## OVERVIEW

### Introduction

Comfrey is an plant belonging to the Borganinaceae family, extracts of the leaves and roots of which has been used as an herbal to treat wounds and to decrease pain and inflammation associated with arthritis, sprains and bone fractures. Comfrey, however, also contains pyrrolizidine alkaloids and, when taken orally, can cause sinusoidal obstruction syndrome and severe liver injury.

### Background

Common comfrey (Symphytum officinale) is a perennial herb belonging to the family Borganinaceae which is native to Europe and Asia, but is now found worldwide. Leaf and root extracts have many constituents including allantoin, rosmarinic acid, triterpene saponins, silicic acid, and tannins, believed to be the basis for its antiinflammatory and wound healing activity. However, comfrey also contains several pyrrolizidine alkaloids (symphytine, echimidine, symglandine and lycopsamine) which are toxic and capable of causing sinusoidal obstruction syndrome (previously called veno-occlusive disease) and severe liver injury. Comfrey has been shown to cause similar liver injury in laboratory animals and has also been linked to liver cancer. Comfrey products are marketed as herbal teas, root powders and as capsules. Oral comfrey has been banned or restricted in most countries, but topical forms (ointments, creams and liniments) are available and advertised as useful for wound healing sprains and bone fractures. Human studies have shown that comfrey creams have mild analgesic effects and decreases muscle and joint pain.

### Hepatotoxicity

Several cases of acute liver injury resembling sinusoidal obstruction syndrome (SOS) due to oral comfrey have been published. The injury usually arises within 1 to 2 months of starting the comfrey product (either extract in tablet form or large amounts of comfrey tea) with onset of right upper quadrant pain, nausea and weight gain (from fluid retention) followed by jaundice. Serum aminotransferase levels are usually only mildly elevated with a hepatocellular pattern of injury, although they may be markedly increased if tested during the early phases of the injury. Immunoallergic and autoimmune features are usually not present. The injury can be severe and rapidly lead to acute liver failure (acute sinusoidal obstruction syndrome), but more commonly presents insidiously with weight gain, ascites, weakness, and minimal serum aminotransferase elevations (subacute or chronic sinusoidal obstruction syndrome).

Likelihood score: C (when taken orally, a probable cause of clinically apparent liver injury due to sinusoidal obstruction syndrome).

### Mechanism of Injury

The pyrrolizidine alkaloids contained in comfrey include intermedine, lycopsamine, symphtine and echnimidine, which are metabolized by the cytochrome P450 enzymes into highly toxic pyrrole metabolites which have alkylating properties that can damage hepatic endothelial cells and can cause sinusoidal obstruction. The amount of pyrrolizidine alkaloids in comfrey varies by the part of the plant used, its age and time of harvesting. The toxicity of pyrrolizidine containing substances is increased by microsomal enzyme inducers such as phenobarbital. Infants appear to be particularly susceptible to pyrrolizidine alkaloid injury.

### Outcome and Management

Hepatotoxicity from comfrey is now rare, as it is widely accepted as being toxic when taken internally and oral formulations are restricted or banned in most countries. Management should be directed at limiting further injury and specific treatment of complications (ascites, variceal bleeding). Anticoagulants have not been shown to be beneficial. Difibrotide (a complex mixture of single stranded DNA prepared from pig intestine) has recently been approved for therapy of severe SOS accompanied by renal or pulmonary failure occurring after myeloablation for hematopoietic cell transplantation. More extensive description of sinusoidal obstruction syndrome and its management are given in the introductory section and in discussion of the antineoplastic alkylating agents.

Other Names: Black root, common comfrey, knitbone

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Comfrey – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Comfrey | 84696-05-9 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 24 May 2022

Abbreviations used: HDS, herbal and dietary supplements; SOS, sinusoidal obstruction syndrome.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; comfrey is discussed as a pyrrolizidine containing herbal that has been linked to veno-occlusive disease which is now referred to as sinusoidal obstruction syndrome [SOS]).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] mentions that comfrey is one of more than 350 plant species that contain pyrrolizidine alkaloids and is capable of causing sinusoidal obstruction syndrome).
Comfrey. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 291-22. (Compilation of short monographs on herbal medications and dietary supplements).
McGee J, Patrick RS, Wood CB, Blumgart LH. (1976). A case of veno-occlusive disease of the liver in Britain associated with herbal tea consumption. J Clin Pathol. (26 year old woman developed abdominal pain and ascites, having used herbal tea for 2 years [bilirubin 0.8 mg/dL, ALT 28 U/L, Alk P 303 U/L], with splenomegaly, varices and intractable ascites, biopsy showing sinusoid obstruction syndrome; dying after failed portocaval shunt, analysis of tea showed pyrrolizidine alkaloids).
Stillman AS, Huxtable R, Consroe P, Kohnen P, Smith S. (1977). Hepatic veno-occlusive disease due to pyrrolizidine (Senecio) poisoning in Arizona. Gastroenterology. (6 month old developed distended abdomen and vomiting [bilirubin 0.5 mg/dL, AST 794 U/L] and was found to have ascites and biopsy showed sinusoidal obstruction syndrome; child had been fed large quantities of locally brewed tea which was made from Senecio longilobus).
Fox DW, Hart MC, Bergeson PS, Jarrett PB, Stillman AE, Huxtable RJ. (1978). Pyrrolizidine (Senecio) intoxication mimicking Reye’s syndrome. J Pediatr. (2 month old boy developed vomiting and hematemesis and hepatic encephalopathy after being given herbal tea [gordolobo] for 4 days [bilirubin normal, but rising to 19.3 mg/dL, ALT 1860 U/L] initially diagnosed as Reye syndrome, dying after 3 days, autopsy showing severe acute sinusoidal obstruction syndrome).
Mattocks AR. (1980). Toxic pyrrolizidine alkaloids in comfrey. Lancet. (Measured pyrrolizidine alkaloids in dried comfrey leaves, finding lowest concentration in mature large leaves and variation by time of harvesting).
Roitman JN. (1981). Comfrey and liver damage. Lancet. (Analysis of tea made from commercially available comfrey found a cup to contain 26 mg of pyrrolizidine alkaloids, well above the amount that has been linked to serious hepatic injury when taken long term).
(1984). Editorial. Pyrrolizidine alkaloids. Lancet. (Plants have evolved poisons that are toxic to insects, but can also cause hepatic sinusoidal obstruction syndrome (veno-occlusive disease) in grazing animals and in humans who ingest these in teas and herbal medications: “a disastrous discontinuity of tradition”).
Ridker PM, Ohkuma S, McDermott WV, Trey C, Huxtable RJ. (1985). Hepatic venocclusive disease associated with the consumption of pyrrolizidine-containing dietary supplements. Gastroenterology. (49 year old woman developed edema and ascites after taking comfrey capsules and tea for 6 months [no liver test results provided], biopsy showing sinusoidal obstruction syndrome, ultimately requiring portocaval shunt with subsequent slow clinical improvement after stopping comfrey ingestion).
Kumana CR, Ng M, Lin HJ, Ko W, Wu PC, Todd D. (1985). Herbal tea induced hepatic veno-occlusive diseases; quantification of toxic alkaloid exposure in adults. Gut. (Four young women brewed Indian herbal tea to treat psoriasis and 3 developed ascites from sinusoidal obstruction syndrome 19-45 days later [bilirubin 0.6, 0.6 and 3.3 mg/dL, ALT 63, 122 and 69 U/L], one dying of hepatic failure, analysis of tea revealed pyrrolizidine alkaloids).
Culvenor CCJ. (1985). Pyrrolizidine alkaloids: some aspects of the Australian involvement. Trends Pharmacol Sci. (Presence of pyrrolizidine alkaloids in several common Australian weeds is a health hazard to livestock and humans; these include Heliotropium europaeum, Echium plantagineum, Senecio and Crotalaria species).
Huxtable RJ, Luethy J, Zweifel U. (1986). Toxicity of comfrey-pepsin preparations. N Engl J Med. (Analysis of two commercial brands of comfrey-pepsin preparations sold as a digestive aid demonstrated pyrrolizidine alkaloids [symphytine and symglandine] in concentrations that could cause sinusoidal obstruction syndrome after a few months of regular intake).
Weston CF, Cooper BT, Davies JD, Levine DF. (1987). Veno-occlusive disease of the liver secondary to ingestion of comfrey. Br Med J (Clin Res Ed). (13 year old boy developed fever, abdominal pain and ascites after several years of treatment with an herbal tea containing comfrey for Crohn’s disease [bilirubin 1.5 mg/dL, AST 87 U/L, Alk P normal], biopsy showing sinusoidal obstruction syndrome).
Roulet M, Laurini R, Rivier L, Calame A. (1988). Hepatic veno-occlusive disease in a newborn infant of a woman drinking herbal tea. J Pediatr. (5 day old girl found to have jaundice, hepatomegaly and ascites [bilirubin 9.6 mg/dL, ALT 760 U/L, protime 13%], biopsy and autopsy showing severe sinusoidal obstruction syndrome and analysis of an herbal tea taken daily by the mother during pregnancy revealed pyrrolizidine alkaloids).
Bach N, Thung SN, Schaffner F. (1989). Comfrey herb tea-induced hepatic veno-occlusive disease. Am J Med. (47 year old woman developed liver test abnormalities and ascites having taken comfrey pills and tea daily for more than a year [bilirubin 1.2 mg/dL, ALT 24 U/L, Alk P 27 U/L], biopsy showing chronic sinusoidal obstruction syndrome).
Ridker PN, McDermont WV. (1989). Hepatotoxicity due to comfrey herb tea. Am J Med. (Letter in response to Bach [1989] reviewing the history of the association of comfrey and pyrrolizidine alkaloids and sinusoidal obstruction syndrome).
Huxtable RJ, Awang DV. (1990). Pyrrolizidine poisoning. Am J Med. (Letter in response to Bach [1989] and Ridker [1989] calling for better documentation of components of implicated hepatotoxic herbs in view of the variable amounts of pyrrolizidine alkaloids found in different comfrey samples due to different species of Symphytum, problems of contamination, mislabeling, use of leaves vs roots and variability in alkaloid content by time of harvest and growing conditions).
Ridker PM, McDermott WV. (1989). Comfrey herb tea and hepatic veno-occlusive disease. Lancet. (Concise review of the hepatotoxicity of comfrey herb tea and its association with sinusoidal obstruction syndrome, probably due to the presence of pyrrolizidine alkaloids which comprise more than 180 compounds and occur in at least 8 plant families; four genera – Heliatropium, Crotalaria, Senecio and Symphytum – accounting for most toxic ingestions).
Yeong ML, Swinburn B, Kennedy M, Nicholson G. (1990). Hepatic veno-occlusive disease associated with comfrey ingestion. J Gastroenterol Hepatol. (23 year old man who had eaten young comfrey leaves for 1-2 weeks developed fatigue and abdominal pain followed in the next 2 months by swelling and edema [bilirubin 1.6 mg/dL, AST 365 U/L, Alk P 475 U/L, INR 1.4], with intractable ascites and hepatic failure; autopsy showed sinusoidal obstruction syndrome).
Carlsson C. (1990). Herbs and hepatitis. Lancet. (Analysis of laboratory results from 395 patients found higher ALT levels among 53 patients taking herbals [55 U/L] than among those who did not [12 U/L]).
Huxtable RJ. (1992). The myth of beneficient nature: the risks of herbal preparations. Ann Intern Med. (Editorial on problems of herbal poisoning highlighting pyrrolizidine alkaloids, comfrey, germander, and suggesting guidelines on their use [never during pregnancy or while nursing, avoiding daily and high doses of a single agent, using products from reputable sources and never using comfrey]).
Miskelly FG, Goodyer LI. (1992). Hepatic and pulmonary complications of herbal medicines. Postgrad Med J. (77 year old woman developed fatigue followed by jaundice 6 months after starting an herbal product with comfrey and skullcap [bilirubin 3.5 mg/dL, AST 520 U/L, Alk P 390 U/L], resolving within 6 months of stopping).
Sperl W, Stuppner H, Gassner J, Judmaier W, Dietze O, Vogel W. (1995). Reversible hepatic veno-occlusive disease in an infant after consumption of pyrrolizidine-containing herbal tea. Eur J Pediatr. (18 month old boy treated with locally prepared herbal tea for over a year presented with ascites and hepatic encephalopathy [bilirubin 2.8 mg/dL, ALT 124 rising to 923 U/L], biopsy showing sinusoidal obstruction syndrome, but gradual improvement and resolution of clinical symptoms and signs after stopping the tea; the plant leaves were likely Adenostyles alliariae [Alpendost], which is known to contain pyrrolizidine alkaloids).
Stickel F, Seitz HK. (2000). The efficacy and safety of comfrey. Public Health Nutr. (Review of comfrey which has a long tradition as an external treatment for inflammatory arthritis and trauma; for internal application it was claimed to be beneficial for gastritis, ulcers, diarrhea and various allergies including asthma; the pyrrolizidine content of comfrey products varies greatly, and hepatic toxicity largely associated with daily intake of tablets or multiple cups of tea).
Stickel F, Seitz HK, Hahn EG, Schuppan D. (2001). Z Gastroenterol. (Review of hepatotoxicity of botanicals including comfrey, pyrrolizidine alkaloids, germander, celandine, chaparral, Chinese herbs and pennyroyal).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions; comfrey is listed as a health tonic that contains toxic pyrrolizidine alkaloids capable of causing sinusoidal obstruction syndrome).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity; discusses comfrey as a cause of sinusoidal obstruction syndrome).
Pak E, Esrason KT, Wu VH. (2004). Hepatotoxicity of herbal remedies: an emerging dilemma. Prog Transplant. (Review of hepatotoxicity of herbal medications stressing the recent rise in numbers of cases, with literature review of comfrey).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] due to herbal medications, but comfrey is not mentioned as a cause).
Seeff LB. (2007). Herbal hepatotoxicity. Clin Liver Dis. (Review of herbal induced hepatotoxicity, with detail of specific herbal compounds including review of the literature on comfrey hepatotoxicity).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals but none were attributed to comfrey).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but none were linked to comfrey).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; comfrey is discussed in the context of pyrrolizidine alkaloid hepatotoxicity).
Giannetti BM, Staiger C, Bulitta M, Predel HG. (2010). Efficacy and safety of a Comfrey root extract ointment in the treatment of acute upper or low back pain: results of a double-blind, randomized, placebo controlled, multicentre trial. Br J Sports Med. (Controlled trial of comfrey root extract ointment versus placebo in 120 patients with acute back pain found significant effect of comfrey ointment on pain intensity and movement; side effects were mild and transient and no more common than with placebo).
Mei N, Guo L, Fu PP, Fuscoe JC, Luan Y, Chen T. (2010). Metabolism, genotoxicity, and carcinogenicity of comfrey. J Toxicol Environ Health B Crit Rev. (Overview of the metabolism and toxicity of comfrey, which refers to several species in the genus Symphytum, most frequently "common comfrey" or S. officinale; the herbal is prepared from leaves and dried roots but is a potential health risk due to pyrrolizidine alkaloids which include retronecine mono- and diesters that are hepatotoxic and carcinogenic in laboratory animals).
Staiger C. (2012). Comfrey: a clinical overview. Phytother Res. (Review of the efficacy and safety of topical comfrey in treatment of arthritis, myalgias, conusions and strains).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including five publications on comfrey).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury discusses pyrrolizidine alkaloids including comfrey as causing sinusoidal obstruction syndrome).
Abdualmjid RJ, Sergi C. (2013). Hepatotoxic botanicals - an evidence-based systematic review. J Pharm Pharm Sci. (A systematic review of hepatotoxic botanicals mentions that comfrey is a common garden plant and consists of several species which contain pyrrolizidine alkaloids that can lead to sinusoidal obstruction syndrome, when taken orally and brewed as teas).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of herbal hepatotoxicity mentions that comfrey is used topically for pain relief, but when taken orally or brewed as a tea it can be associated with sinusoidal obstruction syndrome).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, but none were attributed to comfrey).
Licata A, Macaluso FS, Craxì A. (2013). Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med. (Review and commentary on herbal hepatotoxicity discusses pyrrolizidine alkaloids [including comfrey] which are dose dependent hepatotoxins that cause vino-occlusive disease, probably as a result of biotransformation by the liver to pyrrole derivatives that act as alkylating agents).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality; discusses comfrey which has been used for pain relief, but has been banned in most countries because of its association with severe SOS).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed specifically to a comfrey containing product).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality; mentions that the FDA issued a warning in 2001 about the hepatotoxicity of comfrey).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that comfrey contains pyrrolizidine alkaloids that can cause SOS).
Stickel F, Shouval D. (2015). Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. (Extensive review of liver injury due to HDS, discusses the pyrrolizidine alkaloids and the clinical features, diagnosis and management of SOS).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], however, none of the HDS products listed included comfrey as a known component).
Frenzel C, Teschke R. (2016). Herbal hepatotoxicity: clinical characteristics and listing compilation. Int J Mol Sci. (Extensive listing of herbal products that have been implicated in causing liver injury, including comfrey).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci. (Review and tabulation of HDS causes of liver injury focusing upon illicit anabolic steroids, green tea, linoleic acid, usnic acid, Herbalife and Hydroxycut products, OxyELITE Pro, vitamin A, Ma Huang [ephedra] and Garcinia cambogia).
Avigan MI, Mozersky RP, Seeff LB. (2016). Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci. (Summary of the regulatory issues surrounding HDS products and hepatotoxicity in the US, including difficulties of surveillance, causality assessment, detection of contaminants and FDA regulatory actions using examples of Lipokinetix [usnic acid], OxyELITE Pro [Aegeline], Hydroxycut [possibly green tea] and designer [anabolic] steroids; no specific discussion of comfrey).
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. (2017). Liver injury from herbal and dietary supplements. Hepatology. (Summary of a workshop on the increase in frequency of HDS associated liver injury in the US, focusing upon green tea extracts, OxyELITE Pro, anabolic steroid jaundice and exploring issues of chemical analysis of HDS products, possible changes in regulatory requirements and needs for future research; comfrey is not specifically discussed).
de Boer YS, Sherker AH. (2017). Herbal and dietary supplement-induced liver injury. Clin Liver Dis. (Review of the role of HDS in causing liver injury, mentions comfrey as a source of pyrrolizidine alkaloid associated SOS occurring in the US).
Wong LL, Lacar L, Roytman M, Orloff SL. (2017). Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc. (Among 2408 adult urgent liver transplants enrolled in the US Scientific Registry of Transplant Recipients between 2003 and 2015, 625 [30%] were listed as drug induced, mostly due to acetaminophen [n=300, 48%], and HDS products were the 4th most common cause [n=21, 3%], seemingly increasing in proportion during the 12 years of enrollment; comfrey was not among the agents listed).
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al., Drug Induced Liver Injury Network (DILIN). (2017). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the state of Delaware. Drug Saf. (In a statewide prospective registry of drug induced liver injury, 23 cases were identified during 2014 in Delaware, of which 6 [43%] were attributed to HDS products, but none listed comfrey as a component).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists four publications of case reports implicating comfrey in causing liver injury, probably veno-occlusive disease due to pyrrolizidine alkaloids).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], none were attributed to comfrey).
Kucera A, Barna M, Holcova S, Horacek O, Hladiková M, Ottillinger B. (2018). Tolerability and effectiveness of an antitrauma cream with comfrey herb extract in pediatric use with application on intact and on broken skin. Int J Pediatr Adolesc Med. (Among 712 children treated with a topical cream containing comfrey for up to two weeks, only one had a local adverse reaction [redness and burning] and “These were otherwise no systemic or other adverse reactions”).
Avila C, Breakspear I, Hawrelak J, Salmond S, Evans S. (2020). A systematic review and quality assessment of case reports of adverse events for borage (Borago officinalis), coltsfoot (Tussilago farfara) and comfrey (Symphytum officinale). Fitoterapia. (Literature review and “quality assessment” of reports of hepatotoxicity of three botanical products that can contain pyrrolizidine alkaloids including comfrey).
Kuchta K, Schmidt M. (2020). Safety of medicinal comfrey cream preparations (Symphytum officinale s.l.): The pyrrolizidine alkaloid lycopsamine is poorly absorbed through human skin. Regul Toxicol Pharmacol. (In vitro assays of human skin tissue and lycopsamine [a pyrrolizidine alkaloid found in comfrey] demonstrated its poor absorption through human skin).
Wang Z, Han H, Wang C, Zheng Q, Chen H, Zhang X, Hou R. (2021). Hepatotoxicity of pyrrolizidine alkaloid compound intermedine: comparison with other pyrrolizidine alkaloids and its toxicological mechanism. Toxins (Basel). (In vitro studies of the toxicity of the pyrrolizidine alkaloid found in comfrey [intermedine] for hepatocytes suggested that injury was caused by release of reactive oxygen species leading to mitochondrial mediated apoptosis).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while none were attributed to comfrey).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature identified 446 publications with a total of 936 cases of liver injury attributed to 79 different herbal products, the most common being He Shou Wu [n=91], green tea [90] Herbalife products [64], kava [62] and greater celandine [48]; comfrey was listed as the cause of 8 cases).

## OTHER REFERENCE LINKS

1 Recent References on Comfrey: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=comfrey+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Comfrey: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=comfrey)